# Fluorouracil

## OVERVIEW

### Introduction

Fluorouracil (5-FU) is a pyrimidine analogue used as an antineoplastic agent to treat multiple solid tumors including colon, rectal, breast, gastric, pancreatic, ovarian, bladder and liver cancer. Fluorouracil is associated with a low rate of transient serum aminotransferase elevations during therapy and has been implicated in rare cases of clinically apparent acute liver injury.

### Background

Fluorouracil (floo" oh ure' a sil) is a fluoropyrimidine that has antineoplastic action against several solid tumors including breast and colon cancers. Fluorouracil is believed to block thymidylate synthase and decrease production of thymidylate, a necessary precursor of DNA. This action interferes with the synthesis of DNA, RNA and protein and blocks cell division. Fluorouracil was approved for use as an anticancer agent in the United States in 1962 and is currently used as an important component of several anticancer drug regimens. Fluorouracil is typically combined with leucovorin (folinic acid) which also inhibits thymidylate synthase, thus enhancing the effects of fluorouracil. Current indications for fluorouracil with leucovorin include palliative therapy of advanced breast, bladder, colon, rectum, liver, pancreas and stomach cancer. Fluorouracil is available in various sized vials of 50 mg/mL generically and under several brand names including Adrucil and Carac. The typical recommended dose is 12 mg/kg given intravenously daily for 4 days and, if tolerated, again on days 6, 8 and 12 as a part of 30 day cycles of chemotherapy. In addition, fluorouracil has been used as a continuous hepatic arterial infusion in management of hepatic metastases from colorectal and other cancers. Fluorouracil is also available topically in creams and solutions for therapy of actinic keratoses and basal cell cancers. Common side effects of intravenous therapy include bone marrow suppression, fatigue, weakness, headache, dizziness, insomnia, paresthesias, abdominal pain, constipation, diarrhea, dyspepsia, nausea, stomatitis, rash, and hand-foot syndrome.

### Hepatotoxicity

Several forms of hepatotoxicity have been associated with fluorouracil therapy. Serum aminotransferase elevations occur in up to 70% of patients treated with cyclic courses of fluorouracil, the rate of abnormalities being partially dose related. The aminotransferase elevations are usually transient and mild, are not commonly above 5 times the upper limit of normal and rarely associated with symptoms. The elevations may be associated with hepatic steatosis, which can be demonstrated by hepatic imaging and has been confirmed by liver biopsies that show variable degrees of macrovesicular steatosis and portal inflammation. The injury rarely leads to clinically apparent liver injury. Isolated case reports of clinically apparent acute liver injury with jaundice attributed to fluorouracil have been published, but such cases are rare and the relatedness to fluorouracil remains unclear. Intrahepatic artery infusion of fluorouracil is also associated with serum aminotransferase elevations or chemical hepatitis (in 5% to 7% of cases) and in biliary abnormalities, but it rarely causes biliary strictures or the sclerosing cholangitis-like syndrome that is common with floxuridine (FUDR) treatment. In systematic reviews of the literature, biliary strictures suggestive of sclerosing cholangitis have occurred in <1% of patients treated with hepatic arterial infusions of fluorouracil as compared to 5% to 12% of those given floxuridine. Infusions of fluorouracil can also result in marked shrinkage of metastatic tumors in the liver and partial atrophy of the noninvolved liver, resulting in an irregular lobular appearance suggestive of cirrhosis.

A separate and distinct syndrome associated with fluorouracil therapy is the rapid development of coma with hyperammonemia, lactic acid elevations and respiratory alkalosis that occurs most frequently with continuous infusions of high doses of fluorouracil. The onset is generally within 1 to 2 days of starting infusions and is marked by progressive confusion and stupor followed by coma. Standard liver tests such as ALT, AST, alkaline phosphatase and bilirubin are usually normal, but plasma ammonia levels are high (generally >250 μg/dL) and accompanied by varying degrees of respiratory alkalosis, elevations in serum lactate and azotemia. Infectious complications are common, but most patients recover rapidly with hydration and supportive care. Patients who develop this syndrome can later tolerate lower doses of fluorouracil, but recurrences have been reported. The mortality rate is approximately 10%, most deaths being due to sepsis rather than hepatic failure. The cause of the syndrome is not known, but it is associated with higher doses of chemotherapy. This syndrome has not been reliably linked to other pyrimidine analogues such as capecitabine.

Likelihood score: A (well known cause of clinically apparent liver injury).

### Mechanism of Injury

While severe hepatotoxicity from fluorouracil may be rare, when it occurs it is likely due to direct or intrinsic hepatotoxicity. The injury may be caused by inhibition of thymidylate synthase. In addition, fluorouracil is extensively metabolized in the liver via the microsomal enzyme system, and production of a toxic intermediate may trigger liver injury. The hyperammonemic coma that occurs with high dose infusions of fluorouracil is likely due to inhibition of mitochondrial function, which may be particularly clinically manifest in persons with an underlying, inherited but subclinical mitochondrial enzyme defect. However, fluorouracil readily crosses the blood-brain barrier and some of the toxicity may be due to a direct effect on the central nervous system.

### Outcome and Management

The severity of the liver injury linked to fluorouracil therapy is generally mild. Fluorouracil has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information on cross sensitivity to hepatic injury between fluorouracil and other pyrimidine analogues.

Drug Class: Antineoplastic Agents

Other Drugs in the Subclass, Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Gemcitabine, Trifluridine/Tipracil

## CASE REPORT

### Case 1. Hyperammonemic coma due to fluorouracil.

[Modified from: Advani PP, Fakih MG. 5-FU-induced hyperammonemic encephalopathy in a case of metastatic rectal adenocarcinoid successfully rechallenged with the fluoropyrimidine analog, capecitabine. Anticancer Res 2011; 31: 335-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/21273620)]

A 70 year old woman with metastatic colorectal cancer developed confusion and coma 2 days after a second course of fluorouracil, leucovorin and bevacizumab. She had been treated in the previous year with combination chemotherapy, including fluorouracil (2 g/m^2^), folinic acid, oxaliplatin and bevacizumab as 46 hour continuous infusions every 2 weeks. Because of gastrointestinal toxicity, the chemotherapy was discontinued, but repeat imaging suggested disease progression and she was restarted on fluorouracil, folinic acid and bevacizumab. Two days after finishing the second cycle of this modified regimen, she developed nausea, vomiting, weakness, diarrhea and confusion. Her mental status deteriorated and she developed coma. She had no known history of liver or neurologic disease. Her other medications included atenolol, hydrochlorothiazide, omeprazole, dexamethasone, warfarin, aprepitant and multivitamins. Laboratory tests showed normal complete blood counts and electrolytes. The serum bilirubin was 0.6 mg/dL, ALT 50 U/L, AST 54 U/L and alkaline phosphatase 79 U/L (all within the normal range). Serum ammonia, however, was markedly elevated at 203 μmol/L (normal 11-51). Computerized tomography of the head was normal. She was treated with supportive care and serum ammonia levels fell into the normal range within 24 hours. She improved clinically and was discharged. In follow up, fluorouracil and leucovorin were stopped and she was treated with capecitabine and bevacizumab. She had no recurrence of symptoms and plasma ammonia levels remained normal on multiple occasions.

#### Key Points

Medication: | Fluorouracil (2.4 g/m^2^ daily as 46 hour infusions)
Pattern: | None
Severity: | Coma
Latency: | 3-4 days
Recovery: | Complete within 24 to 48 hours
Other medications: | Leucovorin, bevacizumab, atenolol, hydrochlorothiazide, omeprazole, warfarin, multivitamins

#### Comment

An elderly woman with advanced, metastatic colorectal cancer developed hyperammonemic coma within a few days of starting a second cycle of fluorouracil with leucovorin and bevacizumab. Although she had metastatic liver disease, all liver tests were normal. Lactic acid levels and arterial blood gases were not reported. As in other cases of hyperammonemic coma due to fluorouracil, however, recovery was rapid even with simple supportive therapy including hydration and monitoring. In many instances, there is recurrence if fluorouracil is restarted. This report was important in that capecitabine (a prodrug of fluorouracil) therapy was not associated with recurrence. The cause of the hyperammonemia is unknown, but it is likely from the liver rather than brain, and is probably due to direct inhibition of mitochondrial function and urea cycle enzyme activity by the pyrimidine analogue. Dehydration may play an accessory role in this syndrome.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluorouracil – Generic, Adrucil®, Carac®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Fluorouracil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluorouracil | 51-21-8 | C4-H3-F-N2-O2 | Fluorouracil Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 02 February 2018

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; mentions that fluorouracil can cause liver injury which is typically hepatocellular and likely to be intrinsic [direct]).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3r ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DPl. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1677-730. (Textbook of pharmacology and therapeutics).
Bateman JR, Pugh RP, Cassidy FR, Marshall GJ, Irwin LE. 5-fluorouracil given once weekly: comparison of intravenous and oral administration. Cancer 1971; 28: 907-13. (Comparison of once weekly intravenous vs oral 5-FU therapy in 107 patients with advanced solid organ tumors; hepatic toxicity was "seen infrequently"). 5111743
Massey WH, Fletcher WS, Judkins MP, Dennis DL. Hepatic artery infusion for metastatic malignancy using percutaneously placed catheters. Am J Surg 1971; 121: 160-4. (Description of use of percutaneous placed hepatic artery catheters for administration of 5-FU to patients with metastatic cancer; two patients developed hepatic coma who had "pre-coma" before therapy). 4100063
Smith JP, Randall GE, Castro JR, Lindberg RD. Hypogastric artery infusion and radiation therapy for advanced squamous cell carcinoma of the cervix. Am J Roentgenol Radium Ther Nucl Med 1972; 114: 110-5. (Pilot study of use of surgically implanted gastric artery catheter for administration of 5-FU with leucovorin or methotrexate to 63 patients with metastatic or advanced cancer, reported 3 patients with mild, 6 with moderate and 4 with severe liver toxicity). 5009403
Vestfrid MA, Castelleto L, Giméz PO. [Diffuse liver necrosis in treatment with 5-fluorouracil]. Rev Clin Esp 1972; 125: 549-50. (29 year old man with a mesothelioma developed nausea within 4 days of starting intravenous fluorouracil [1 mg daily] and died two days later, autopsy showing massive centrolobular necrosis). 5074970
Vaughan WP, Wilcox PM, Alderson PO, Ettinger DS, Abeloff MD. Hepatic toxicity of adjuvant chemotherapy for carcinoma of the breast. Med Pediatr Oncol 1979; 7: 351-9. (Among 24 women with advanced breast cancer who received chemotherapy with 5-FU, cyclophosphamide and methotrexate, 4 developed hepatotoxicity as marked by mild Alk P elevations and abnormal liver scans 3-20 months after starting therapy, suggestive of tumor but showing inflammation only by liver biopsy, resolving upon stopping chemotherapy). 547161
Daly JM, Kemeny N, Oderman P, Botet J. Long-term hepatic arterial infusion chemotherapy. Arch Surg 1984; 119: 935-41. (40 patients with metastatic colorectal cancer underwent hepatic arterial infusions with FUDR; toxic effects were largely gastrointestinal with ulcers [30%], gastritis without ulcers [18%], elevations in bilirubin >3 mg/dL [23%], AST [65%], and extrahepatic bile duct strictures [5%]). 6378147
Kemeny MM, Goldberg DA, Browning S, Metter GE, Miner PJ, Terz JJ. Experience with continuous regional chemotherapy and hepatic resection as treatment of hepatic metastases from colorectal primaries. A prospective randomized study. Cancer 1985; 55: 1265-70. (Among 46 patients with hepatic metastases from colorectal cancer treated with continuous hepatic artery infusions of FUDR, 58% had chemical hepatitis with ALT or AST >3 times ULN and mild jaundice, 8 also developed biliary strictures and 6 of the first 19 required cholecystectomy for cholecystitis; one patient with strictures died of hepatic failure). 3971296
Sugarbaker PH, Gianola FJ, Speyer JC, Wesley R, Barofsky I, Meyers CE. Prospective, randomized trial of intravenous versus intraperitoneal 5-fluorouracil in patients with advanced primary colon or rectal cancer. Surgery 1985; 98: 414-22. (Among 65 patients with advance colorectal cancer treated with 12 cycles of increasing doses of 5-FU, ALT elevations occurred in 60% of those given intraperitoneal vs 67% given intravenous 5-FU). 3898450
Caruso U, Elli M, Cravotto E, Tisone G, Lombardo PA, Silvaroli M, Ficorella C, Cortesi E, Casciani CU. Colorectal cancer (Duke's group B2, C1, C2): adjuvant chemotherapy and toxicity. Mt Sinai J Med 1985; 52: 470-2. (Among 15 patients with colorectal cancer and hepatic metastases treated with cyclic intravenous 5-FU and methyl CCNU, none developed evidence of hepatic toxicity). 3875028
Luquel L, Ekherian JM, De Gramont A, Offenstadt G. [Anuria, hepatocellular insufficiency and bone marrow aplasia after the administration of streptozocin and fluorouracil]. Therapie 1988; 43: 125. French. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%202970126) (52 year old woman with metastatic carcinoid cancer developed anuria and jaundice after a 2nd 5 day course of streptozocin and fluorouracil [bilirubin 11.9 mg/dL, ALT 1280 U/L], dying 8 days later, injury attributed to streptozocin).
Mitchell RB, Wagner JE, Karp JE, Watson AJ, Brusilow SW, Przepiorka D, Storb R, et al. Syndrome of idiopathic hyperammonemia after high-dose chemotherapy: review of nine cases. Am J Med 1988; 85: 662-7. (Idiopathic hyperammonemia was found in 5 of 210 patients being treated for leukemia and 3 of 250 patients undergoing bone marrow transplantation; all 9 had disorientation progressing to coma; liver tests were usually normal, ammonia levels were high [mean=589 µmol/L], most were neutropenic, 6 died and 3 survived, chemotherapy included cytarabine, daunomycin, vincristine, amsacrine, etoposide, cyclophosphamide). 3189370
Kemeny N, Seiter K, Martin D, Urmacher C, Niedzwiecki D, Kurtz R, et al. A new syndrome: ascites, hyperbilirubinemia, and hypoalbuminemia after biochemical modulation of fluorouracil with N-phophonacetyl-L-aspartate (PALA). Ann Intern Med 1991; 115: 946-51. (Among 44 patients with metastatic colon cancer who received fluorouracil with PALA [an inhibitor of pyrimidine synthesis], 5 patients developed ascites usually with mild jaundice and serum enzyme elevations, with hypoalbuminemia and coagulopathy and fatty change on liver biopsy, improving on stopping treatment, suggestive of L-asparaginase hepatotoxicity). 1824554
Stenram U. Hepatotoxicity of fluorouracil with N-phosphonacetyl-L-aspartate. Ann Intern Med 1992; 117: 90-1. (Letter in response to Kemeny [1991] suggesting that the toxicity was due to 5-FU and its incorporation into hepatic tissue RNA). 1530700
Moertel CG, Fleming TR, Macdonald JS, Haller DG, Laurie JA. Hepatic toxicity associated with fluorouracil plus levamisole adjuvant therapy. J Clin Oncol 1993; 11: 2386-90. (Among 376 patients with advanced colorectal cancer treated with cycles of 5-FU and levamisole, 149 [40%] developed hepatotoxicity compared to 16% on levamisole alone and 16% of untreated patients, with variable elevations in ALT, Alk P and bilirubin arising 1-12 months after starting chemotherapy and resolving with stopping in all except 7 patients; liver biopsy in 3 patients showed macrovesicular steatosis and imaging suggested fatty liver). 8246027
Klotz HP, Weder W, LargiadèF. Local and systemic toxicity of intra-hepato-arterial chemotherapy for treatment of unresectable liver metastases of colorectal cancer with 5-Fluorouracil and high dose Leucovorin. Helv Chir Acta 1993; 60: 283-6. (Among 6 patients who received 24 cycles of hepatic artery infusions of fluorouracil, at least one liver test abnormality occurred during 42% of cycles, but all were mild [grade 1] and rapidly resolved). 8226075
Liaw CC, Liaw SJ, Wang CH, Chiu MC, Huang JS. Transient hyperammonemia related to chemotherapy with continuous infusion of high-dose 5-fluorouracil. Anticancer Drugs 1993; 4: 311-5. (7 patients, 4 men and 3 women, ages 44 to 68, with advanced cancer treated with high dose intravenous 5-FU developed hyperammonemia 1.5-4 days after starting [bilirubin and ALT normal in all, creatinine 0.7-4.6 mg/dL, ammonia 33-2387 µg/dL], resolving rapidly [<2 days]; 1 died of septic shock). 8358058
Yeh KH, Cheng AL. Acute confusion induced by a high-dose infusion of 5-fluorouracil and folinic acid. J Formos Med Assoc 1994; 93: 721-3. (61 year old man with gastric cancer developed coma 2 days after a second 1 day course of intravenous 5-FU and leucovorin, which lasted 40 hours and recurred after another infusion, ammonia levels not reported). 7858459
Frasci G, Leone F, Monaco M, Cremone L, Sapio U, Faiella F, Espinosa A, et al. 5-Fluorouracil-interferon-alpha 2b adjuvant treatment of Dukes C colorectal cancer. Dis Colon Rectum 1994; 37: 643-50. (Among 57 patients with advanced colorectal cancer treated with fluorouracil and alpha interferon, 4 [7%] developed transient liver test abnormalities, all of which resolved after therapy was stopped). 8026229
Figueredo AT, Fawcet SE, Molloy DW, Dobranowski J, Paulseth JE. Disabling encephalopathy during 5-fluorouracil and levamisole adjuvant therapy for resected colorectal cancer: a report of two cases. Cancer Invest 1995; 13: 608-11. (Two of 82 patients treated with 5-FU and levamisole for colorectal cancer developed progressive dementia while receiving chemotherapy that improved minimally upon stopping; liver enzymes were normal and ammonia not tested). 7583711
Langer CJ, Hageboutros A, Kloth DD, Roby D, Shaer AH. Acute encephalopathy attributed to 5-FU. Pharmacotherapy 1996; 16: 311-3. (65 year old man with adenocarcinoma treated with 5-FU, leucovorin and cisplatin developed lethargy and coma within 48 hours of starting treatment, with normal serum enzymes and no jaundice, which resolved within 1-2 weeks and did not recur with subsequent courses of lower doses of 5-FU). 8820478
Ross P, Norman A, Cunningham D, Webb A, Iveson T, Padhani A, Prendiville J, Watson M, Massey A, Popescu R, Oates J. A prospective randomised trial of protracted venous infusion 5-fluorouracil with or without mitomycin C in advanced colorectal cancer. Ann Oncol 1997; 8: 995-1001. (Among 200 patients with advanced colorectal cancer treated with 5-FU infusions with or without mitomycin C for up to 24 weeks, common side effects were mucositus, hand-foot syndrome, diarrhea, nausea, alopecia and bone marrow suppression; no mention of ALT elevations or hepatotoxicity). 9402173
Hirvikoski PP, Kumpulainen EJ, Johansson RT. Hepatic toxicity caused by adjuvant CMF/CNF in breast cancer patients and reversal by tamoxifen. Breast Cancer Res Treat 1997; 44: 269-74. (Among 194 patients with advanced breast cancer who received adjuvant chemotherapy with or without tamoxifen, minor elevations in AST, Alk P and GGT occurred in patients who received cyclophosphamide with methotrexate and 5-FU alone, but not in those who also received tamoxifen, but no patient developed clinically apparent liver injury or stopped therapy because of enzyme elevations alone). 9266107
Yeh KH, Cheng AL. High-dose 5-fluorouracil infusional therapy is associated with hyperammonaemia, lactic acidosis and encephalopathy. Br J Cancer 1997; 75: 464-5. (Among 280 patients with advanced metastatic cancer treated with high doses of infusional 5-FU, 16 [6%] developed encephalopathy 10-30 hours after starting the infusion and lasting 3-72 hours, accompanied by lactic acidosis [4 to >12 mg/dL, normal .1.3] and hyperammonemia [149 to >500 µmol/L, normal .43], all except one patient recovered completely). 9020500
Bygrave HA, Geh JI, Jani Y, Glynne-Jones R. Neurological complications of 5-fluorouracil chemotherapy: case report and review of the literature. Clin Oncol (R Coll Radiol) 1998; 10: 334-6. (Two patients with adenocarcinoma treated with 5-FU [one also received cis-platinin] developed neurologic syndrome with neuropathy that improved slowly and incompletely after stopping). 9848338
Valik D. Encephalopathy, lactic acidosis, hyperammonaemia and 5-fluorouracil toxicity. Br J Cancer 1998; 77: 1710-2. (Letter in response to Yeh [1997] suggesting that the patients who developed hyperammonemia might have had preexisting, incomplete forms of mitochondrial enzyme defects). 9635854
Locatelli M, Colleoni M, Noberasco C, Nolé, Orlando L, Munzone E, Peruzzotti G, Goldhirsch A. Hepatic toxicity from cyclophosphamide, methotrexate, fluorouracil (CMF regimen). Ann Oncol 1999; 10: 1394-5. (Among 264 patients treated with adjuvant chemotherapy with cyclophosphamide, methotrexate and 5-FU, 106 [40%] had liver enzyme elevations, but were >5 times ULN in only 20 [8%]; the increases usually occurred with first few courses and were transient in all, returning to normal within 30 days and resulting in dose modification in 11% of cycles, delay in 3% and permanent discontinuation in only 1%). 10631475
Liaw CC, Wang HM, Wang CH, Yang TS, Chen JS, Chang HK, Lin YC, et al. Risk of transient hyperammonemic encephalopathy in cancer patients who received continuous infusion of 5-fluorouracil with the complication of dehydration and infection. Anticancer Drugs 1999; 10: 275-81. (29 patients with cancer receiving high dose, continuous infusions of 5-FU developed 32 episodes of encephalopathy, arising 0.5-5 days after starting with ammonia 248 to 2387 µg/dL, often accompanied by azotemia or infection, usually resolving within 2 days; ALT, Alk P and bilirubin normal; deaths due to sepsis). 10327032
Soori GS, Oldham RK, Dobbs TW, Bury MJ, Church CK, DePriest C. Chemo-biotherapy with 5-fluorouracil, leucovorin, and alpha interferon in metastatic carcinoma of the colon.a Cancer Biotherapy Research Group [CBRG] phase II study. Cancer Biother Radiopharm 2000; 15: 175-83. (Among 16 patients with advanced colorectal cancer treated with fluorouracil and leucovorin weekly and alpha interferon thrice weekly, AST elevations occurred in 19% and Alk P and bilirubin in 12%, but it was difficult to separate drug toxicity from tumor progression as a cause of abnormalities). 10803323
Pirzada NA, Ali II, Dafer RM. Fluorouracil-induced neurotoxicity. Ann Pharmacother 2000; 34: 35-8. (73 year old man with esophageal carcinoma treated with intravenous fluorouracil [1.5 g daily for 4 days] developed confusion 2 days after stopping [ammonia and lactate normal], resolving within 3 days but with residual ataxia). 10669184
Yamano T, Takayasu Y, Nakao N, Kubota A. [Evaluation of hepatic toxicity following high-dose 5-FU arterial infusion chemotherapy: analysis of 42 cases of colorectal liver metastases]. Nihon Igaku Hoshasen Gakkai Zasshi 2000; 60: 94-102. Japanese. (Among 42 patients with metastatic colorectal cancer treated with hepatic arterial infusions of 5-FU, Alk P levels were elevated in 19 [46%] and CT scans showed fatty liver in 6 patients [14%], in whom biopsies showed fat and portal inflammation; other patients had lobular changes to liver with shrinkage of metastases and atrophic changes in the residual liver). 10741116
Barnett KT, Malafa MP. Complications of hepatic artery infusion: a review of 4580 reported cases. Int J Gastrointest Cancer 2001; 30: 147-60. (Systematic review of literature on complications of hepatic artery infusion therapy of cancer; in 23 randomized trials, mortality rate 1% with "chemical hepatitis" in 5% using 5-FU alone vs 31% with FUDR alone, biliary toxicity in <1% vs 14% and sclerosing cholangitis in <1% vs 12%). 12540027
Ishii H, Furuse J, Nagase M, Yoshino M, Kawashima M, Satake M, Ogino T, Ikeda H. Hepatic arterial infusion of 5-fluorouracil and extrabeam radiotherapy for liver metastases from pancreatic carcinoma. Hepatogastroenterology 2004; 51: 1175-8. (Among 17 patients with liver metastases from pancreatic cancer treated with hepatic arterial infusions of 5-FU, none developed "liver dysfunction" from the chemotherapy). 15239272
Takamori H, Kanemitsu K, Tsuji T, Tanaka H, Chikamoto A, Nakahara O, Hiraoka T, et al. 5-fluorouracil intra-arterial infusion combined with systemic gemcitabine for unresectable pancreatic cancer. Pancreas 2005; 30: 223-6. (24 patients with pancreatic cancer were treated with intraarterial infusions of fluorouracil [to tumor and liver] 5 days a week for 3 weeks of every 4; gastric and duodenal ulcers occurred in 17% and cholangitis in 21%, requiring biliary drainage, but none resulted in death). 15782098
Sandrasegaran K, Alazmi WM, Tann M, Fogel EL, McHenry L, Lehman GA. Chemotherapy-induced sclerosing cholangitis. Clin Radiol 2006; 61: 670-8. (Description of 11 patients with FUDR [n=9] or 5-FU [n=2] induced sclerosing cholangitis who underwent ERCP at a single institution; onset after 2-132 months of therapy with jaundice, pruritus or liver test abnormalities [bilirubin 0.4 to 17.6 mg/dL, Alk P 191-1106 U/L]). 16843750
Kim YA, Chung HC, Choi HJ, Rha SY, Seong JS, Jeung HC. Intermediate dose 5-fluorouracil-induced encephalopathy. Jpn J Clin Oncol 2006; 36: 55-9. (68 year old man developed mental changes on the 5th day of a second course of fluorouracil and cisplatin infusions [bilirubin 1.6 mg/dL, ALT 23 U/L, ammonia 354 ug/dL], resolving within 1 day of stopping the infusions recurring in milder form during a 3rd and 4th cycle). 16436463
Heluwaert F, Santre C, Martin C, Hilleret MN, Martin D. [Coma following chemotherapy: is 5FU implicated? Discussion about on case-report]. Gastroenterol Clin Biol 2006; 30: 325-6. French. (56 year old woman with colon cancer developed confusion followed by coma 5 days after a 24 hour intravenous course of fluorouracil [~2 g] with leucovorin [lactate 13.8 mEq/L, arterial pH 7.35, creatinine 6.4 mg/dL], resolving rapidly with hydration and support, ammonia levels normal when tested at time of recovery). 16565673
Formica V, Leary A, Cunningham D, Chua YJ. 5-Fluorouracil can cross brain-blood barrier and cause encephalopathy: should we expect the same from capecitabine? A case report on capecitabine-induced central neurotoxicity progressing to coma. Cancer Chemother Pharmacol 2006; 58: 276-8. (46 year old woman with colon cancer developed disorientation and coma during the 4th cycle of capecitabine and oxaliplatin adjuvant therapy, but with normal liver tests and ammonia, resolving with stopping capecitabine). 16333678
Alazmi WM, McHenry L, Watkins JL, Fogel EL, Schmidt S, Sherman S, Lehman GL. Chemotherapy-induced sclerosing cholangitis: long-term response to endoscopic therapy. J Clin Gastroenterol. 2006; 40: 353-7. (Description of 11 patients with FUDR [n=9] or 5-FU [n=2] induced sclerosing cholangitis who underwent ERCP at a single institution, strictures were typically in the common hepatic duct near the bifurcation). 16633109
Nott L, Price TJ, Pittman K, Patterson K, Fletcher J. Hyperammonemia encephalopathy: an important cause of neurological deterioration following chemotherapy. Leuk Lymphoma 2007; 48: 1702-11. (Review of hyperammonemic coma which can occur with cancer chemotherapy [usually fluorouracil] or after bone marrow transplant). 17786705
Brooks AJ, Begg EJ, Chapman BA, Fitzharris BM. Two cases of severe liver injury possibly related to 5-fluorouracil and calcium folinate. Intern Med J 2007; 37: 344-5. (Two cases with liver injury and jaundice after 5-FU therapy of colon cancer: 66 year old man developed jaundice 6 weeks after finishing 30 weekly courses of 5-FU and leucovorin [bilirubin 30.7 mg/dL, ALT 866 U/L, Alk P 170 U/L], resolving within 4 months; 62 year old man developed jaundice 2 weeks after an initial 5 day cycle of daily 5-FU and leucovorin [bilirubin 3.7 mg/dL, ALT 433 U/L, Alk P 425 U/L], resolving within 4 months of stopping chemotherapy). 17504289
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/20949552) (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, including 2 attributed to antineoplastic agents, 1 to melphalan and 1 to gemtuzumab, but none to fluorouracil or other antimetabolites).
Wolf PS, Park JO, Bao F, Allen PJ, DeMatteo RP, Fong Y, Jarnagin WR, et al. Preoperative chemotherapy and the risk of hepatotoxicity and morbidity after liver resection for metastatic colorectal cancer: a single institution experience. J Am Coll Surg 2013; 216: 41-9. (Among 250 patients who received preoperative chemotherapy with fluorouracil and other agents before liver resection for metastatic colorectal cancer, steatosis in the non-tumorous liver was associated with irinotecan [46% vs 31%], higher BMI [44% vs 18%] and diabetes [52% vs 32%], and major liver complications were associated with the size of the resection not chemotherapy regimen). 23041049
Vincenzi B, Imperatori M, Picardi A, Vespasiani Gentilucci U, Gallo P, Fausti V, Spalato Ceruso M, et al. Liver toxicity in colorectal cancer patients treated with first-line FOLFIRI-containing regimen: a single institution experience. Expert Rev Anticancer Ther 2015; 15: 971-6. (Among 156 patients with metastatic colorectal cancer undergoing chemotherapy with folinic acid, fluorouracil and irinotecan [FOLFIRI], ALT, AST and Alk P elevations were frequent in a "mixed" pattern causing delay in courses in 16%, decrease in doses in 8% and discontinuation in 2%). 26112080
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2025754159) (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 [5.5%] were attributed to antineoplastic agents, but none to use of fluorouracil).
Kusano M, Honda M, Okabayashi K, Akimaru K, Kino S, Tsuji Y, Watanabe M, et al. Randomized controlled Phase III study comparing hepatic arterial infusion with systemic chemotherapy after curative resection for liver metastasis of colorectal carcinoma: JFMC 29-0003. J Cancer Res Ther 2017; 13: 84-90. (Among 91 patients with metastatic colorectal cancer who received fluorouracil intravenously or by intrahepatic arterial infusion, adverse event rates were similar, but rates of treatment interruption and discontinuation were higher with the direct hepatic artery infusions; no mention of ALT elevations or hepatotoxicity). 28508838
Guo JH, Zhang HY, Gao S, Zhang PJ, Li XT, Chen H, Wang XD, et al. Hepatic artery infusion with raltitrexed or 5-fluorouracil for colorectal cancer liver metastasis. World J Gastroenterol 2017; 23: 1406-11. (Among 24 patients with metastatic colorectal cancer treated with intraarterial fluorouracil and oxaliplatin, median survival was 15 months and enzyme elevations occurred in 79%, which were above 5 times ULN in 29%). 28293087

## OTHER REFERENCE LINKS

1. Recent References on Fluorouracil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Fluorouracil/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fluorouracil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fluorouracil)